# Suvorexant

## OVERVIEW

### Introduction

Suvorexant is an orexin receptor antagonist used for the treatment of insomnia and sleep disorders. Suvorexant therapy is associated with rare occurrence of transient serum enzyme elevations but has not been implicated in cases of clinically apparent liver injury.

### Background

Suvorexant (soo" voe rex' ant) is an orexin receptor antagonist which is used to treat insomnia. Central nervous system neurons with orexin receptors are involved in wakefulness and are inactive during sleep. Engagement of the orexin receptor results in wakefulness, and loss of the receptor can result in excessive daytime sleepiness and narcolepsy. Inhibition of orexin receptor signaling using suvorexant has been shown to shorten the time to falling asleep and to prolong sleep in patients with sleep-onset and sleep-maintenance insomnia. Suvorexant was approved for use in the United States in 2014, the first such orexin based drug approved for insomnia. Suvorexant is available in 5, 10, 15 and 20 mg tablets under the brand name Belsomra. The recommended dose is 10 mg taken orally within 30 minutes of bedtime. The dose can be increased to 20 mg. Side effects are few, but may include daytime somnolence, fatigue, dizziness, headache and vivid or abnormal dreams. Rare but potentially severe side effects include sleep paralysis, cataplexy, nightmares, excessive daytime sleepiness, worsening of depression and suicidal ideation and behaviors. Suvorexant can also decrease respiratory function and should be used with caution in persons with respiratory illnesses. Suvorexant is classified as a Schedule 4 controlled substance, meaning that it has a low potential for abuse or dependence and has an approved medical use.

### Hepatotoxicity

In several clinical trials, suvorexant was found to be well tolerated, with serum ALT elevations in 0 to 5% of patients, usually with higher doses, and resolving spontaneously without dose modification. In the registration trials of suvorexant, there were no reports of clinically apparent liver injury. Suvorexant has been available for more than a decade but has not been implicated in causing clinically apparent liver injury even with an overdose.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which suvorexant might cause liver injury is unknown. Suvorexant is metabolized by the cytochrome P450 system (predominantly CYP3A4), and the dose may need to be altered in patients taking strong inhibitors (decreasing dose) or inducers (increasing dose) of the enzymes. The relative lack of serious liver related adverse events is probably due to the low doses used and its uncommon, intermittent use.

Drug Class: Sedatives and Hypnotics; Drugs for Insomnia

Other Orexin Receptor Antagonists: Daridorexant, Lemborexant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Suvorexant – Belsomra®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=suvorexant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Suvorexant | 1030377-33-3 | C23-H23-Cl-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 05 February 2025

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; suvorexant and the orexin receptor antagonists are not discussed).
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455-6. (Review of hepatotoxicity of hypnotics and sedatives discusses benzodiazepines, buspirone and valerian, all of which have been linked to rare cases of liver injury; suvorexant and orexin receptor antagonists are not discussed).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-354. (Textbook of and therapeutics, discusses suvorexant).
FDA. Cross-Discipline Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2014/204569Orig1s000MedR.pdf (FDA website with product labels and multiple disciplinary review that supported approval of suvorexant in the US, mentions that there were no hepatic serious adverse events, no discontinuations for hepatic events, and no significant shift or change in serum ALT or AST levels during therapy, no instance of ALT elevation with jaundice, and in registration trials enrolling more than 2,500 subjects, ALT elevations of more than 3 times ULN arose in 0.5% of suvorexant and 0.3% of placebo recipients).
Herring WJ, Snyder E, Budd K, Hutzelmann J, Snavely D, Liu K, Lines C, et al. Orexin receptor antagonism for treatment of insomnia: a randomized clinical trial of suvorexant. Neurology 2012; 79: 2265-74. (Among 254 patients treated with one of 4 doses of suvorexant or placebo in a cross over design, adverse events were more common with higher doses and consisted mainly of somnolence [2-12%], headache [0-5%], dizziness [0-5%] and abnormal dreams [0-5%], with rare instances of ALT elevations [1.6-3.4% with higher doses vs 0.4% with placebo], all of which resolved spontaneously without dose modification). 23197752
Herring WJ, Connor KM, Ivgy-May N, Snyder E, Liu K, Snavely DB, Krystal AD, et al. Suvorexant in patients with insomnia: results from two 3-month randomized controlled clinical trials. Biol Psychiatry. 2016; 79(2): 136-48. (In two 3-month controlled trials of suvorexant versus placebo for primary insomnia in 2040 patients, “No clinically relevant changes in laboratory … measures were observed” and no serious hepatic adverse events were reported). 25526970
Michelson D, Snyder E, Paradis E, Chengan-Liu M, Snavely DB, Hutzelmann J, Walsh JK, et al. Safety and efficacy of suvorexant during 1-year treatment of insomnia with subsequent abrupt treatment discontinuation: a phase 3 randomised, double-blind, placebo-controlled trial. Lancet Neurol 2014; 13: 461-71. (Among 522 patients with insomnia treated with suvorexant or placebo for one year, rates of adverse events with similar in the two groups and “there were no clinically meaningful differences between groups in vital signs or laboratory values”). 24680372
Yin J, Mobarec JC, Kolb P, Rosenbaum DM. Crystal structure of the human OX (2) orexin receptor bound to the insomnia drug suvorexant. Nature 2015;519(7542):247-50. (Resolution of the crystal structure of the human orexin receptor bound to suvorexant). 25533960
Suvorexant (Belsomra) for insomnia. Med Lett Drugs Ther 2015; 57: 29-31. (Concise review of the efficacy, safety and costs of suvorexant as therapy of insomnia shortly after its approval in the US, mentions the most common side effect as being next day somnolence [in 7-13% of recipients]; no mention of hepatotoxicity or ALT elevations). 25719996
Patel KV, Aspesi AV, Evoy KE. Suvorexant: A dual orexin receptor antagonist for the treatment of sleep onset and sleep maintenance insomnia. Ann Pharmacother 2015;49(4):477-83. (Review of 3 randomized, controlled trials of suvorexant as therapy of insomnia mentions that somnolence, fatigue and headache were more common with drug than placebo; no mention of ALT elevations or hepatotoxicity). 25667197
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 82 [9%] were attributed to agents active in the central nervous system, but none were sedatives or sleeping aids). 25754159
Drugs for insomnia. Med Lett Drugs Ther 2015; 57 (1472): 95-8. (Concise review of the mechanism of action, efficacy, safety and costs of drugs for insomnia including benzodiazepine receptor agonists, benzodiazepines, melatonin receptor agonists, orexin receptor antagonists such as suvorexant and other agents including nonprescription and herbal products; no mention of ALT elevations or hepatotoxicity). 26147892
Schroeck JL, Ford J, Conway EL, Kurtzhalts KE, Gee ME, Vollmer KA, Mergenhagen KA. Review of safety and efficacy of sleep medicines in older adults. Clin Ther 2016; 38: 2340-72. (Systematic review of the literature on the safety and efficacy of sleep aids in the elderly focuses upon common adverse events such as somnolence, fatigue, headache and dry mouth with special emphasis on dementia, forgetfulness, daytime somnolence, falls and fractures; no mention of ALT elevations or hepatotoxicity). 27751669
Kuriyama A, Tabata H. Suvorexant for the treatment of primary insomnia: A systematic review and meta-analysis. Sleep Med Rev 2017; 35: 1-7. (Systematic review of the safety and efficacy of suvorexant does not mention effects on ALT levels or hepatotoxicity). 28365447
Drugs for chronic insomnia. Med Lett Drugs Ther. 2018;60:201-205. (Concise review of the mechanisms of action, relative clinical efficacy, safety and costs of medications used to treat chronic insomnia mentions that suvorexant’s most common adverse events are somnolence, fatigue and nightmares and that it may cause impairment of next day driving performance and rarely has been linked to complex-sleep related disorders such as cataplexy and leg weakness; no mention of ALT elevations or hepatotoxicity). 30625122
Borchert JS, Wang B, Ramzanali M, Stein AB, Malaiyandi LM, Dineley KE. Adverse events due to insomnia drugs reported in a regulatory database and online patient reviews: comparative study. J Med Internet Res. 2019;21:e13371. (Search of regulatory databases of adverse event reports attributed to drugs for insomnia discusses suvorexant, the main reported side effects being nightmares, headache, somnolence, sleep paralysis, abnormal dreams, feeling abnormal, insomnia, and hangover; no mention of liver test abnormalities or hepatotoxicity). 31702558
Muehlan C, Vaillant C, Zenklusen I, Kraehenbuehl S, Dingemanse J. Clinical pharmacology, efficacy, and safety of orexin receptor antagonists for the treatment of insomnia disorders. Expert Opin Drug Metab Toxicol. 2020;16:1063-1078. (Review of the role of orexin in sleep and wakefulness, and the mechanism of action, pharmacology, clinical efficacy and safety of orexin receptor antagonists including suvo-, lembo-, darido- and seltorexant, all of which have similar side effects but are generally “well tolerated”). 32901578
Ito H, Ogawa Y, Shimojo N, Kawano S. Suvorexant poisoning in a patient with cirrhosis and renal failure. Cureus. 2021;13:e14329. (83 year old man with nonalcoholic steatohepatitis and cirrhosis, hepatocellular carcinoma and renal failure took 270 mg of suvorexant [18 of his 15 mg tablets] in a suicide attempt and slept for 10 hours but then presented with normal cognition, no sedation, no asterixis and normal ALT, AST, alkaline phosphatase, bilirubin and INR, with no worsening of his renal failure). 33968537
Preskorn SH. Comparative pharmacology of the 3 marketed dual orexin antagonists-daridorexant, lemborexant, and suvorexant-part 2. principal drug metabolizing enzyme, drug-drug interactions, and effects of liver and renal impairment on metabolism. J Psychiatr Pract. 2023;29:38-41. (Review of the pharmacokinetics of the 3 orexin antagonists in clinical use, including suvo-, lembo-, and daridorexant, mentions that they have similar chemical structures and similar metabolism by CYP 3A4, with only minor differences in susceptibility to inducers and inhibitors of CYP 3A4). 36649550
Drugs for chronic insomnia. Med Lett Drugs Ther. 2023;65:1-6. (Concise description of drugs approved for use in chronic insomnia including relative efficacy, safety and costs, mentions that orexin receptor inhibitors improve latency to falling asleep by 5-10 minutes and duration of sleep to waking by 15-25 minutes compared to placebo and that the most common adverse events are somnolence, fatigue, headache, and abnormal dreams; no mention of ALT elevations or hepatotoxicity). 36630579
Pan B, Ge L, Lai H, Hou L, Tian C, Wang Q, Yang K, et al. The comparative effectiveness and safety of insomnia drugs: a systematic review and network meta-analysis of 153 randomized trials. Drugs. 2023;83:587-619. (Systematic review of the literature on the safety of drugs for insomnia identified 61 trials with 25,093 patients, and while the frequency of common adverse events varied, “with respect to serious and drug related adverse events, there were no differences among the drugs’; no mention of liver related adverse events). 36947394

## OTHER REFERENCE LINKS

1. Recent References on Suvorexant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Suvorexant+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Suvorexant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Suvorexant)